# Loperamide

## OVERVIEW

### Introduction

Loperamide is synthetic opioid that primarily affects opiate receptors in the intestine and is used to treat diarrhea. Loperamide has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Loperamide (loe per’ a mide) is a synthetic piperidine derivative that acts as a mild opiate receptor agonist (predominant µ type receptors), but is used largely for the treatment of diarrhea rather than pain. Loperamide is not structurally related to morphine or codeine and has minimal or no euphoric or analgesic effects, apparently because it is poorly absorbed orally and is actively transported out of the central nervous system. Loperamide acts as a potent opiate agonist in the intestine and reduces intestinal motility, causing a slowing of intestinal transport and increased resorption of water and electrolytes, actions that are helpful in treating diarrhea. Loperamide was approved for use in the United States in 1976 and is still widely used to treat acute diarrhea caused by gastroenteritis, as well as the chronic diarrhea of inflammatory bowel disease. Loperamide is available as tablets and capsules of 2 mg and solution of 1 mg/5 mL generically and under the brand name Imodium. The usual dose of loperamide in adults is 4 mg initially, followed by 2 mg after each unformed stool, not to exceed 16 mg daily. Side effects of loperamide include abdominal bloating and pain, nausea and vomiting and constipation. Rare side effects include hypersensitivity reactions and paralytic ileus. Loperamide is not classified as a controlled substance and several formulations are available without prescription.

### Hepatotoxicity

As with most opiates in current use, therapy with loperamide has not been linked to serum enzyme elevations. There have been no convincing cases of idiosyncratic acute, clinically apparent liver injury attributed to either agent. The reason for its lack of hepatotoxicity may relate to the low doses used and lack of significant systemic absorption. What loperamide is absorbed is metabolized in the liver.

References on the safety and potential hepatotoxicity of loperamide are given in the overview section of the Opioids. Last updated: 20 May 2019

Drug Class: Gastrointestinal Agents; Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Loperamide – Generic, Imodium®

DRUG CLASS

Gastrointestinal Agents; Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Loperamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Loperamide | 53179-11-6 | C29-H33-Cl-N2-O2 | Loperamide Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Loperamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Loperamide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Loperamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Loperamide)